# Alectinib

## OVERVIEW

### Introduction

Alectinib is a tyrosine kinase receptor inhibitor and antineoplastic agent used in the therapy of selected forms of non-small cell lung cancer. Alectinib is associated with a high rate of serum aminotransferase elevations during therapy and with rare instances of clinically apparent acute liver injury.

### Background

Alectinib (al ek' ti nib) is a small molecule tyrosine kinase receptor inhibitor with potent activity against anaplastic lymphoma kinase (ALK) that is rearranged and mutated in selected cancers, including 2% to 4% of non-small cell lung cancer (NSCLC). The mutated, rearranged ALK promotes unregulated cell growth and proliferation and is sometimes overexpressed in cancer cells. Alectinib has been found to inhibit mutated ALK in cell culture and in several clinical trials was found to induce objective responses in a proportion of patients with refractory, advanced NSCLC that are ALK-positive. Alectinib was approved for use in the United States in 2015 in patients with ALK-positive, metastatic NSCLC who have progressed despite therapy with first generation ALK inhibitors (such as crizotinib). The indications were subsequently expanded to initial therapy of ALK-positive metastatic NSCLC (2017) and to adjuvant therapy after complete resection of early stage ALK-positive NSCLC (2024). Alectinib is available in capsules of 150 mg under the brand name Alecensa. The recommended dose is 600 mg twice daily, continued until disease progression or intolerable toxicity occurs. Side effects are common and can include fatigue, constipation, peripheral edema and myalgia. Uncommon, but potentially severe side effects include interstitial lung disease, severe myalgia, bradycardia, renal impairment, liver injury, hemolytic anemia and embryo-fetal toxicity.

### Hepatotoxicity

In preregistration trials of alectinib, ALT elevations occurred in up to 60% of patients, but values above 5 times the upper limit of normal (ULN) were found in only 1% to 5%. Alectinib therapy was also associated with frequent elevations in alkaline phosphatase (47%) and bilirubin (39%), but these abnormalities were usually transient, asymptomatic, and mild-to-moderate in degree. Clinically apparent liver injury with jaundice was rare, but cases were reported and at least 2% of alectinib treated subjects discontinued therapy early because of liver test abnormalities. In subsequent controlled trials, liver test abnormalities arose in 41% of alectinib treated patients and were above five times ULN in 8%, leading to early discontinuation in 4%, and 3 patients were judged to have drug induced liver injury.

Since the approval and more widescale use, several cases of clinically apparent liver injury attributed to alectinib have been published. Injury typically arose within 1 to 3 months of starting, and enzyme patterns ranged from hepatocellular to cholestatic. Immune allergic features (rash, fever) and autoantibodies were rare. Some cases were severe, and several cases recurred upon restarting. Analyses of adverse event reporting databases suggest that liver related reports are less frequent with alectinib that crizotinib or ceritinib, two other ALK inhibitors.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

Serum enzyme and bilirubin elevations are frequent during therapy with tyrosine kinase inhibitors, but their cause is not known. The liver injury may be due to direct activity against essential intracellular kinases or to production of a toxic metabolite during metabolism. Alectinib is metabolized in the liver predominantly by CYP 3A4, but has not been linked to significant drug-drug interactions.

### Outcome and Management

Liver injury due to alectinib varies in severity from minor, transient serum enzyme elevations to acute symptomatic liver injury with jaundice. Monitoring of liver tests is recommended in the product label, before initiating treatment and then every 2 weeks for 3 months and monthly thereafter as clinically indicated. Serum aminotransferase elevations above 5 times the upper limit of normal should lead to temporary discontinuation, which should be permanent if laboratory values do not improve significantly or resolve within a few weeks or if symptoms or jaundice arise. Restarting therapy is usually, but not always, followed by recurrence of the liver test abnormalities. There appears to be little cross sensitivity to liver injury among the ALK receptor inhibitors, and switching to another ALK inhibitor may be appropriate.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Alectinib – Alecensa®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Alectinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Alectinib | 1256580-46-7 | C30-H34-N4-O2 | SID: 163643281

## ANNOTATED BIBLIOGRAPHY

References updated: 09 August 2026

Abbreviations: ALK, anaplastic lymphoma kinase; NSCLC, non-small cell lung cancer; ULN, upper limit of normal.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556-7. (Review of hepatotoxicity of cancer chemotherapeutic agents published in 2013; discusses the hepatotoxicity of crizotinib, but not alectinib or ceritinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. Drugs: https://www.accessdata.fda.gov/drugsatfda_docs/nda/2015/208434Orig1s000MedR.pdf (FDA Drug Approvals website with product labels and the full FDA clinical review of data submitted by the sponsor on the safety and efficacy of alectinib in support of its approval mentions that ALT elevations arose in up to 61% of patients and were above 5 times ULN in 5% (usually within 2 months of starting) leading to dose modifications in 4% and early discontinuations in 2 patients who were judged to have drug induced liver injury although none had bilirubin elevations and both resolved with stopping drug).
"https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/208434Orig1s015MultidisciplineR.pdf" (https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/208434Orig1s015MultidisciplineR.pdf) Shaw AT, Engelman JA. ALK in lung cancer: past, present, and future. J Clin Oncol 2013; 31: 1105-11. PMID: (Review of the history of discovery of ALK mutations and development of crizotinib as therapy of patients with NSCLC and this mutation, as well as next-generation ALK inhibitors in development; no discussion of hepatotoxicity or ALT elevations). 23401436
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. PMID: (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the United States as of 2013; crizotinib is listed as causing liver enzyme elevations in up to 57% of patients [ above 5 times ULN in 6%] and to having been linked cases of hepatitis and fatal hepatic failure; no mention of alectinib or ceritinib). 23620168
Seto T, Kiura K, Nishio M, Nakagawa K, Maemondo M, Inoue A, Hida T, et al. CH5424802 (RO5424802) for patients with ALK-rearranged advanced non-small-cell lung cancer (AF-001JP study): a single-arm, open-label, phase 1-2 study. Lancet Oncol 2013; 14: 590-8. PMID: (Among 46 patients with ALK-positive NSCLC treated with alectinib [up to 300 mg twice daily], 93% had an objective response, and side effects included ALT elevations in 10 patients [22%] which were above 5 times ULN in one [2%] and bilirubin elevations in 28%, but most changes resolved without symptoms or residual injury, although one patient was reported to have developed sclerosing cholangitis). 23639470
Gadgeel SM, Gandhi L, Riely GJ, Chiappori AA, West HL, Azada MC, Morcos PN, et al. Safety and activity of alectinib against systemic disease and brain metastases in patients with crizotinib-resistant ALK-rearranged non-small-cell lung cancer(AF-002JG): results from the dose-finding portion of a phase 1/2 study. Lancet Oncol 2014; 15: 1119-28. PMID: (Among 47 patients with ALK-positive NSCLC resistant to crizotinib therapy who were treated with alectinib [300-900 mg twice daily], 54% had an objective response, and side effects included fatigue [30%], myalgia [17%], edema [17%], and ALT elevations [13%], but none were above 5 times ULN). 25153538
McKeage K. Alectinib: a review of its use in advanced ALK-rearranged non-small cell lung cancer. Drugs 2015; 75: 75-82. PMID: (Review of the development of alectinib, its structure, pharmacology, efficacy, and safety; mentions a case of sclerosing cholangitis arising during therapy [Seto 2013], but does not discuss ALT elevations or hepatotoxicity). 25428710
Larkins E, Blumenthal GM, Chen H, He K, Agarwal R, Gieser G, Stephens O, et al. FDA approval: alectinib for the treatment of metastatic, ALK-positive non-small cell lung cancer following crizotinib. Clin Cancer Res 2016; 22 (21): 5171-6. PMID: (Review of clinical trial results that supported the FDA-accelerated approval of alectinib for crizotinib-refractory, ALK-positive NSCLC which included safety data on 253 patients in whom common side effects were fatigue [41%], constipation [34%], edema [30%], myalgia [29%] and increased ALT [34%], bilirubin [39%] and alkaline phosphatase levels [47%]; 4 patients had ALT elevations above 5 times ULN, and 2 were diagnosed with drug induced liver injury). 27413075
Ou SH, Ahn JS, De Petris L, Govindan R, Yang JC, Hughes B, Lena H, et al. Alectinib in crizotinib-refractory ALK-rearranged non-small-cell lung cancer: a phase II global study. J Clin Oncol 2016; 34: 661-8. PMID: (Among 138 patients with crizotinib- refractory, ALK-positive NSCLC treated with alectinib, the objective response rate was 79% and common side effects were constipation, fatigue and peripheral edema, while ALT elevations arose in 10% of patients and were above 5 times ULN in 2%, but there were no liver related discontinuations or cases of ALT elevations with jaundice). 26598747
Shaw AT, Gandhi L, Gadgeel S, Riely GJ, Cetnar J, West H, Camidge DR, et al.; study investigators. Alectinib in ALK-positive, crizotinib-resistant, non-small-cell lung cancer: a single-group, multicentre, phase 2 trial. Lancet Oncol 2016; 17: 234-42. PMID: (Among 87 patients with ALK-positive, crizotinib-resistant NSCLC treated with alectinib [600 mg twice daily], the objective response rate was 48%, and side effects included constipation [36%], fatigue [33%], myalgia [24%], peripheral edema [23%] and ALT elevations [26%], which were above 5 times ULN in 5%, with two patients discontinuing therapy early because of "serious liver injury" although no specific details provided). 26708155
Jassem J. Alectinib in crizotinib-resistant, ALK-positive NSCLC. Lancet Oncol 2016; 1: 134-5. PMID: (Editorial accompanying publication by Shaw [2016] discussing the promises and challenges of the second-generation ALK inhibitors such as alectinib and ceritinib). 26708154
Hida T, Nokihara H, Kondo M, Kim YH, Azuma K, Seto T, Takiguchi Y, et al. Alectinib versus crizotinib in patients with ALK-positive non-small-cell lung cancer (J-ALEX): an open-label, randomised phase 3 trial. Lancet 2017; 390 (10089): 29-39. PMID: (Among 207 Japanese patients with ALK-positive NSCLC treated with alectinib or crizotinib for an average of 12 months, progression free survival was greater with alectinib while adverse events were less including ALT elevations [9% vs 32%] which were above 5 times ULN in 1% vs 13%). 28501140
Gainor JF, Shaw AT. J-ALEX: alectinib versus crizotinib in ALK-positive lung cancer. Lancet 2017; 390 (10089): 3-4. PMID: (Editorial in response to Hida [2017] mentions the greater potency against ALK and better brain penetration of alectinib compared to crizotinib). 28501139
Tamura T, Kiura K, Seto T, Nakagawa K, Maemondo M, Inoue A, Hida T, et al. Three-year follow-up of an alectinib phase I/II study in ALK-positive non-small-cell lung cancer: AF-001JP. J Clin Oncol 2017; 35: 1515-21. PMID: (Further follow up of 46 patients with ALK-positive NSCLC treated with alectinib, identified 25 patients still on therapy after 3 years and adverse events included AST elevations in 33% and 6 patients who discontinued therapy because of side effects including one for sclerosing cholangitis and one for ALT elevations above 5 times ULN). 28296581
Peters S, Camidge DR, Shaw AT, Gadgeel S, Ahn JS, Kim DW, Ou SI, et al.; ALEX Trial Investigators. Alectinib versus crizotinib in untreated ALK-positive non-small-cell lung cancer. N Engl J Med 2017; 377: 829-38. PMID: (Among 303 patients with previously untreated, advanced ALK-positive NSCLC treated with alectinib [600 mg twice daily] or crizotinib after 18 months of follow up, progression free survival was higher with alectinib [59% vs 32%], while severe adverse events were less frequent [41% vs 50%], including ALT elevations [15% vs 30%], and those above 5 times ULN [5% vs 15%] and those requiring discontinuation [1% vs 3%]). 28586279
Zhu VW, Lu Y, Ou SI. Severe acute hepatitis in a patient receiving alectinib for ALK-positive non-small-cell lung cancer: histologic analysis. Clin Lung Cancer 2019; 20: e77-e80. PMID: (50 year old woman with advanced, recurrent NSCLC despite therapy with crizotinib, developed ALT [~200 to 350 U/L] without bilirubin elevations [less than 1.0 mg/dL] or symptoms 5 months after starting alectinib which on biopsy demonstrated severe hepatitis with bridging necrosis and which eventually improved on stopping and did not then reoccur on restarting). 30318176
Li J, Yuan Z, Wang Q, Fan W, Zhang G. Meta-analysis of overall incidence and risk of ALK inhibitors-induced liver toxicities in advanced non-small-cell lung cancer. Medicine (Baltimore) 2019; 98: e13726. PMID: (In an analysis of 12 clinical trials of ALK inhibitors in 2418 patients, ALT elevations arose in 26% overall and were above 5 times ULN in 8%; overall rates of ALT elevations were higher with ceritinib [56%] than with crizotinib [28%] or alectinib [13%]). 30608384
Camidge DR, Dziadziuszko R, Peters S, Mok T, Noe J, Nowicka M, Gadgeel SM, et al. Updated efficacy and safety data and impact of the EML4-ALK fusion variant on the efficacy of alectinib in untreated ALK-positive advanced non-small cell lung cancer in the global phase III ALEX study. J Thorac Oncol 2019; 14: 1233-43. PMID: (Among 303 patients with ALK-positive NSCLC treated with alectinib or crizotinib [Peters 2017], after 35 months of follow up, median progression free survival was higher with alectinib [35 vs 11 months], while severe adverse events rates were similar [30.3% vs 30.5%], but rates of ALT elevations were lower [17% vs 35%]). 30902613
Zhou C, Kim SW, Reungwetwattana T, Zhou J, Zhang Y, He J, Yang JJ, et al. Alectinib versus crizotinib in untreated Asian patients with anaplastic lymphoma kinase-positive non-small-cell lung cancer (ALESIA): a randomised phase 3 study. Lancet Respir Med 2019; 7: 437-446. PMID: (Among 187 Asian patients with previously untreated ALK-positive NSCLC treated with alectinib or crizotinib, progression free survival was longer with alectinib, while serious adverse events [15% vs 26%] were less frequent). 30981696
Mok T, Camidge DR, Gadgeel SM, Rosell R, Dziadziuszko R, Kim DW, Pérol M, et al. Updated overall survival and final progression-free survival data for patients with treatment-naive advanced ALK-positive non-small-cell lung cancer in the ALEX study. Ann Oncol 2020; 31: 1056-1064. PMID: (Among 303 patients with ALK-positive NSCLC treated with alectinib or crizotinib [Peters 2017], after 42 months of follow up, both median progression free survival [35 vs 11 months] and overall 5-year survival rates were higher with alectinib [63% vs 46%], and while severe adverse events rates were similar, rates of ALT elevations above 5 times ULN were lower [5% vs 16%]). 32418886
Duarte FA, Rodrigues LB, Paes FR, Diniz PHC, Lima HFCA. Successful treatment with alectinib after crizotinib-induced hepatitis in ALK-rearranged advanced lung cancer patient: a case report. BMC Pulm Med 2021; 21: 43. PMID: (32 year old woman with ALK-positive NSCLC developed acute hepatitis 2 to 3 months after starting crizotinib [ALT rising to 9145 U/L, bilirubin 7.9 mg/dL] that resolved within 2 months of stopping, and she then tolerated alectinib without recurrence of liver injury). 33509141
Makimoto G, Kawakado K, Nakanishi M, Tamura T, Kuyama S. Successful treatment with lorlatinib after the development of alectinib-induced liver damage in ALK-positive non-small-cell lung cancer: a case report. Case Rep Oncol 2021; 14: 197-201. PMID: (57 year old Japanese man with ALK-positive lung adenocarcinoma developed liver injury 79 days after starting alectinib [bilirubin ~4 mg/dL, ALT ~ 410 U/L], that resolved rapidly upon stopping and recurred upon restarting at a reduced dose, but then resolved again and he later tolerated lorlatinib [an ALK inhibitor approved for use in Japan] without recurrence). 33776703
Juncu SŞ, Trifan AV, Minea H, Avram RI, Cojocariu C, Sîngeap AM. From spotlight to shadow: ALK inhibitor-induced acute liver failure in a patient with non-small cell lung cancer. Arch Clin Cases 2023; 10: 160-163. PMID: (73 year old man with ALK-positive NSCLC developed jaundice and coagulopathy 5 months after starting alectinib [bilirubin 32 mg/dL, ALT 672 U/L, Alk P 208 U/L, INR 1.73], which resolved with drug discontinuation, N-acetylcysteine, and corticosteroid therapy). 38026106
Wu YL, Dziadziuszko R, Ahn JS, Barlesi F, Nishio M, Lee DH, Lee JS, et al.; ALINA Investigators. Alectinib in resected ALK-positive non-small-cell lung cancer. N Engl J Med 2024; 390: 1265-1276. PMID: (Among 257 patients with completely resected ALK-positive NSCLC treated with adjuvant alectinib [600 mg twice daily] or platinum based chemotherapy [four 21-day cycles], 2-year disease free survival was 94% vs 63%; while serious adverse events rates were higher with alectinib [13% vs 8%] as were ALT elevations [41% vs 2%], and those above 5 times ULN [9% vs none] as well as discontinuations for ALT elevations [2% vs none], but there were no cases of clinically apparent liver injury with jaundice). 38598794
Yang Y, Tan S, Pu Y, Zhang J. Safety profile and hepatotoxicity of anaplastic lymphoma kinase tyrosine kinase inhibitors: a disproportionality analysis based on FDA Adverse Event Reporting System database. Toxics 2025; 13: 210. PMID: (Among 56,864 adverse event reports on ALK inhibitors submitted to the FDAs Adverse Event Reporting System [FAERS] between 2014 and 2024, liver related adverse events accounted for 1,978 [3.5%] reports; 696 attributed to crizotinib, 528 to alectinib, and 451 to certinib). 40137538

## OTHER REFERENCE LINKS

1. Recent References on Alectinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Alectinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Alectinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Alectinib)